# Mefloquine

## OVERVIEW

### Introduction

Mefloquine is a quinoline derivative used for the prevention and therapy of P. falciparum malaria. Mefloquine therapy is associated with a low rate of transient and asymptomatic serum enzyme elevations and is a rare cause of clinically apparent acute liver injury.

### Background

Mefloquine (mef' loe kwin) is a quinoline methanol similar to quinine and is active against the asexual stages of malaria. Its exact mechanism of activity is unknown. Mefloquine is effective as prophylaxis against malaria and is widely used in therapy against chloroquine-resistant P. falciparum infection. Unfortunately, mefloquine resistance is becoming an enlarging problem. Mefloquine was approved for use in the United States in 1989 and is available in tablets of 250 mg in several generic forms and under the brand name Lariam. The recommended dosage for suppressive prophylaxis is 250 mg once weekly for 1 week before to 4 weeks after travel to an endemic area. Specific recommendations on the therapy of malaria including details on diagnosis, drug dosage and safety are available at the CDC website: http://www.cdc.gov/malaria/. Common side effects of mefloquine include headache, fatigue, insomnia, vivid dreams, anorexia, nausea, diarrhea, abdominal discomfort, dizziness, rash and pruritus. Rare side effects include hallucinations, disorientation and seizures.

### Hepatotoxicity

Chronic therapy with mefloquine is associated with asymptomatic, transient serum enzyme elevations in up to 18% of patients. These elevations are usually mild and resolve without dose modifications. Despite widespread use, mefloquine has rarely been linked to clinically apparent acute liver injury and too few reports are available to characterize the clinical features of such injury. Instances of acute hepatocellular injury as well as cholestatic hepatitis have been linked to use of mefloquine. Allergic manifestations (rash, fever, eosinophilia) and autoantibody formation are rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the hepatic injury from mefloquine is unknown, but may relate to a metabolic intermediate with direct toxicity or ability to induce an immune mediated hepatotoxicity. Mefloquine undergoes extensive hepatic metabolism to an inactive metabolite that is excreted in the urine.

### Outcome and Management

There does not seem to be cross reactivity to hepatic injury among the various antimalarial agents and switching to other drug can be done.

Drug Class: Antimalarial Agents

## CASE REPORT

### Case 1. Acute hepatitis due to mefloquine prophylaxis of malaria.

[Modified from: Bruguera M, Herrera S. [Acute hepatitis associated with mefloquine therapy]. Gastroenterol Hepatol 2007; 30: 102-3. Spanish. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17335720)]

A 35 year old woman working in health care in Liberia developed nausea, poor appetite and pruritus 2 months after starting malarial prophylaxis with mefloquine (250 mg weekly). She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She denied fever. On examination, she was jaundiced and had a desquamating erythematous rash over the hands and palms. She had stopped the mefloquine when she first began to feel ill. Laboratory testing showed marked elevations in serum aminotransferase and alkaline phosphatase levels (Table) with a total serum bilirubin of 7.1 mg/dL. The prothombin time was normal. Tests for hepatitis A, B and C were negative. Ultrasound of the abdomen showed no evidence of biliary obstruction. Over the next few days she began to improve. In follow up 5 weeks later, serum liver tests had returned to near normal levels.

#### Key Points

Medication: | Mefloquine (250 mg once weekly)
Pattern: | Hepatocellular (R=10.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 months
Recovery: | 6 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
8 weeks | 7 days | 2411 | 614 | 7.1 | Rash
| 8 days | 2369 | 452 | 8.2
14 weeks | 6 weeks | 66 | 168 | 1.2
Normal Values | | <42 | <115 | <1.2

#### Comment

Despite the frequency of serum aminotransferase elevations during mefloquine therapy, there have been few reports of clinically apparent liver disease with jaundice. The current report described a self limited acute hepatitis-like syndrome arising 2 months after starting a prophylactic regimen of mefloquine. Although the height of the serum aminotransferase levels were indicative of a hepatocellular pattern of injury, the high alkaline phosphatase levels and early presentation with pruritus suggests that the hepatic injury was at least partially cholestatic. This “mixed” pattern is typical of drug induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mefloquine – Generic, Lariam®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mefloquine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mefloquine | 51773-92-3 | C17-H16-F6-N2-O.Cl-H | Chemical Structure for Mefloquine

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2017

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; mentions that mefloquine can lead to elevated ALT levels).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Chemotherapy of malaria.l In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1383-418. (Textbook of pharmacology and therapeutics).
Reisinger EC, Horstmann RD, Dietrich M. Tolerance of mefloquine alone and in combination with sulfadoxine-pyrimethamine in the prophylaxis of malaria. Trans R Soc Trop Med Hyg 1989; 83: 474-7. (Controlled trial of mefloquine alone vs mefloquine and sulfadoxine/pyrimethamine in 175 travelers; ALT or AST became abnormal in 18%, peak ALT 122 U/L with similar frequency in both groups; all resolving spontaneously). 2694482
Lobel HO, Miani M, Eng T, Bernard KW, Hightower AW, Campbell CC. Long-term malaria prophylaxis with weekly mefloquine. Lancet 1993; 341: 848-51. (Study on 421 Peace Corps volunteers in West Africa on different antimalarial regimens including mefloquine, chloroquine and proguanil; no serious adverse events were reported, but ALT levels were not monitored; mefloquine decreased P. falciparum infection rate). 8096560
Steffen R, Fuchs E, Schildknecht J, Naef U, Funk M, Schlagenhauf P, Phillips-Howard P, et al. Mefloquine compared with other malaria chemoprophylactic regimens in tourists visiting east Africa. Lancet 1993; 341: 1299-303. (Inflight questionnaires of returning travelers from East Africa between 1985 and 1991; side effects of mefloquine reported in 17-35% of subjects, higher with combinations; 4 deaths, evidently from malaria). 8098447
Boudreau E, Schuster B, Sanchez J, Novakowski W, Johnson R, Redmond D, Hanson R, et al. Tolerability of prophylactic malaria regimens. Trop Med Parasitol 1993; 44: 257-65. (Controlled trial of mefloquine vs chloroquine in 359 US Marines for 12 weeks; no differences in ALT levels between groups; mefloquine caused mild psychological side effects and insomnia). 8256107
Palmer KJ, Holliday SM, Brogden RN. Mefloquine. A review of its antimalarial activity, pharmacokinetic properties and therapeutic efficacy. Drugs 1993; 45: 430-75. (Review on mefloquine which is used as prophylaxis and treatment of chloroquine resistant P. falciparum malaria; transient increases of ALT have been observed with prophylactic and therapeutic regimens; 4 cases of hepatitis have been reported to the manufacturer). 7682911
Jaspers CAJJ, Hoperus Buma APCC, Van Thiel PPAM, Van Hulst RA, Kager PA. Tolerance of mefloquine chemoprophylaxis in Dutch military personnel. Am J Trop Med Hyg 1996; 55: 230-4. (Study of 73 volunteers on mefloquine for 25 weeks; slight increase in mean ALT levels but no value rose above normal). 8780466
Barrett PJ, Emmins PD, Clarke PD, Bradley DJ. Comparison of adverse events associated with the use of mefloquine and combination of chloroquine and proguanil as antimalarial prophylaxis: a postal and telephone survey of travelers. BMJ 1996; 313: 525-8. (Mail questionnaire of 3851 British travelers taking mefloquine or chloroquine/proguanil for malaria prophylaxis; rates of side effects were similar [~41%], no mention of hepatic adverse events). 8789977
Grieco A, Vecchio FM, Natale L, Gasbarrini G. Acute fatty liver after malaria prophylaxis with mefloquine. Lancet 1999; 353: 295-6. (46 year old developed nausea, weight loss and edema, found to have hepatomegaly and fatty liver [ALT 41 U/L, Alk P 161 U/L, no bilirubin values given], resolving over next month, but relationship to therapy unclear). 9929030
Gotsman I, Azaz-Livshits T, Fridlender Z, Muszkat M, Ben-Chetrit E. Mefloquine-induced acute hepatitis. Pharmacotherapy 2000; 20: 1517-9. (68 year old man developed fatigue and nausea after 6 weeks of mefloquine prophylaxis [bilirubin 1.9 mg/dL, ALT 1277 U/L, LDH 7770 U/L, Alk P normal, INR 7.4], with rapid recovery on stopping; patient also had atrial flutter and heart failure and clinical presentation was more typical of ischemic hepatitis than drug induced liver injury). 11130224
Overbosch D, Schilthuis H, Bienzle U, Behrens RH, Kain KC, Clarke PD, Toovey S, et al. Malarone International Study Team. Atovaquone-proguanil versus mefloquine for malaria prophylaxis in nonimmune travelers: results from a randomized, double-blind study. Clin Infect Dis 2001; 33: 1015-21. (Controlled trial of atovaquone-proguanil vs mefloquine for malaria prophylaxis in 483 travelers; similar efficacy [100%], but neuropsychiatric side effects were more common with mefloquine [29% vs 14%] including insomnia, anxiety, vivid dreams, dizziness and trouble concentrating; no mention of liver injury and ALT levels were not monitored). 11528574
Croft AM, Herxheimer A. Adverse effects of the antimalaria drug, mefloquine: due to primary liver damage with secondary thyroid involvement? BMC Public Health 2002; 2: 6. (Systematic review of 516 published case reports of adverse effects of mefloquine suggests that many such as malaise, fever, anorexia, headache, abdominal pain and nausea are due to “transient, anicteric chemical hepatitis,” although abnormal liver tests are found in only a proportion). 11914150
Croft AM, Whitehouse DP, Cook GC, Beer MD. Safety evaluation of the drugs available to prevent malaria. Expert Opin Drug Saf 2002; 1: 19-27. (Review of adverse side effects of antimalarial agents, pointing out the need for careful prospective randomized controlled trials of prophylactic regimens). 12904156
Taylor WR, White NJ. Antimalarial drug toxicity: a review. Drug Saf 2004; 27: 25-61. (Review of the toxicities and side effects of antimalarials; mentions that mefloquine can cause transient ALT elevations and rarely hepatitis). 14720085
Bruguera M, Herrera S. [Acute hepatitis associated with mefloquine therapy]. Gastroenterol Hepatol 2007; 30: 102-3. Spanish. (35 year old woman physician developed nausea and pruritus followed by jaundice 2 months after starting mefloquine prophylaxis [bilirubin 7.1 mg/dL, ALT 2411 U/L, Alk P 614 U/L], resolving 5 weeks after stopping: Case 1). 17335720
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one case was attributed to artesunate, but no other antimalarial agent was mentioned). 18955056
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to antimalarials). 20648003
Tine RC, Faye B, Sylla K, Ndiaye JL, Ndiaye M, Sow D, Lo AC, et al. Efficacy and tolerability of a new formulation of artesunate-mefloquine for the treatment of uncomplicated malaria in adult in Senegal: open randomized trial. Malar J. 2012 Dec 12; 11: 416. (310 Senegalese patients with malaria were treated with artesunate and mefloquine vs artesunate and lumefantrine for 3 days; both regimens were highly effective and well tolerated, mean serum ALT levels did not change and no serious adverse events were reported). 23234606
Rueangweerayut R, Phyo AP, Uthaisin C, Poravuth Y, Binh TQ, Tinto H, Pénali LK, et al; Pyronaridine–Artesunate Study Team. Pyronaridine-artesunate versus mefloquine plus artesunate for malaria. N Engl J Med 2012; 366: 1298-309. (Among 1271 patients in Asia and Africa treated for malaria with an artesunate combination regimen for 3 days, ALT elevations occurred in none of 423 mefloquine treated, but in 2.5% [21 of 848] of pyronaridine-artesunate treated subjects including 15 with ALT above 5 times ULN and 2 patients with jaundice, but with symptomatic hepatitis). 22475593
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an antimalarial agent). 24552865
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period [2010 and 2011], but none were attributed to an antimalarial agent). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an antimalarial agentl). 25754159
Advice for travelers. Treat Guidel Med Lett 2015: 57 (1466): 52-8. (Concise guidelines on prevention of malaria in travelers indicates that mefloquine can be used as prophylaxis in chloroquine-reistant malaria areas of the world and is an appropriate prophylactic agent for patients who cannot tolerate chloroquine). 25853663

## OTHER REFERENCE LINKS

1. Recent References on Mefloquine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=mefloquine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Mefloquine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=mefloquine)